# Plazomicin

## OVERVIEW

### Introduction

Plazomicin is a parenterally administered, broad spectrum aminoglycoside antibiotic typically used for moderate-to-severe urinary tract infections or pyelonephritis. Plazomicin has had limited clinical use but has not been linked to serum enzyme elevations during therapy or to instances of clinically apparent liver injury.

### Background

Plazomicin (pla" zoe mye' sin) is a semi-synthetic aminoglycoside with broad bacteriocidal activity against many aerobic gram negative and some aerobic gram positive organisms including strains resistant to conventional aminoglycosides. Plazomicin was prepared from sisomicin and modified to evade the most common forms of aminoglycoside resistance. Like other aminoglycosides, plazomicin is thought to act by binding to bacterial ribosomes and inhibiting protein synthesis and is considered bacteriocidal as well as bacteriostatic. Plazomicin is most commonly used for complicated urinary tract infections including pyelonephritis, particularly when drug resistance to conventional aminoglycosides is suspected. Plazomicin was approved for use in the United States in 2018 and is available in solution in 10 mL single-dose vials of 500 mg (50 mg/mL) under the brand name Zemdri. The typical adult dose is 15 mg/kg every 24 hours by intravenous infusion for 4 to 7 days. Doses must be modified based upon renal function, which should be assessed before starting therapy. Common side effects include diarrhea, hypertension, headache, nausea, vomiting and hypotension. Important, dose related adverse effects include oto- and nephrotoxicity, which are shared by all aminoglycosides but are uncommon with short courses of plazomicin. Rare, but potentially severe adverse events also shared with other aminoglycosides include hypersensitivity reactions and Clostridium difficile associated diarrhea.

### Hepatotoxicity

Intravenous therapy with plazomicin has been linked to only rare instances of serum enzyme elevations (<1%), which were largely mild and asymptomatic and which resolved rapidly once the antibiotic course was completed. There have been no reports of acute liver injury with jaundice associated with plazomicin therapy, and despite many years of widespread use, the other aminoglycosides have rarely been linked to instances of clinically apparent liver injury. The cases of suspected aminoglycoside associated liver injury were characterized by a short latency to onset (within 1 to 3 weeks), a mixed or cholestatic pattern of injury and self-limited course. The liver injury was typically accompanied by skin rash, fever and sometimes eosinophilia, suggesting an immunoallergic cause. Chronic liver injury from aminoglycoside toxicity has not been described. Aminoglycosides are not listed or mentioned in large case series of drug induced liver disease and acute liver failure. Thus, hepatic injury due to plazomicin is rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible cause of hepatic injury from plazomicin is not known. Uptake of aminoglycosides into hepatocytes is limited, and they are rapidly excreted in the urine; high concentrations are found mainly in renal tubular cells and hair cells of the inner ear, perhaps explaining why they are more likely to cause nephro- or oto- rather than hepato-toxicity. Liver injury may accompany the rare hypersensitivity reactions to aminoglycosides.

### Outcome and Management

The outcome of hepatic injury due to aminoglycosides is usually benign. Acute liver failure has not been associated with aminoglycoside use and nor has chronic bile duct vanishing syndrome. Patients with clinical apparent reactions to one aminoglycoside should probably avoid use of other systemic aminoglycosides.

An annotated bibliography on the safety and potential hepatotoxicity of plazomicin is provided in the Overview section on the Aminoglycosides (Last updated: December 2018).

Drug Class: Aminoglycosides

Other Drugs in the Class: Amikacin, Gentamicin, Neomycin, Streptomycin, Tobramycin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Plazomicin – Zemdri®

DRUG CLASS

Aminoglycosides

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Plazomicin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Plazomicin | 1154757-24-0 | C25-H48-N6-O10 | Plazomicin chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Plazomicin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Plazomicin/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Plazomicin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=amikacin)